# Tongkat Ali

## OVERVIEW

### Introduction

Tongkat ali (Eurycoma longifolia Jack), also known as “Long Jack”, is a flowering, shrubby, slow growing tree native to Southeast Asia, the leaves, roots, and bark of which have been used extensively in traditional medicine for many conditions including diabetes, arthritis, liver diseases, malaria, dysentery, and erectile dysfunction. It has recently become a popular herbal supplement in the United States, as extracts of tongkat ali roots have been promoted as increasing testosterone levels and improving athletic performance. Reports of clinically apparent liver injury attributed to tongkat ali in body builders have recently appeared.

### Background

Tongkat ali (Eurycoma longifolia), also known as “Long Jack”, is a flowering, shrubby, slender, slow growing evergreen tree native to Southeast Asia, the leaves, roots, and bark of which have been used extensively in traditional medicine for a variety of conditions including diabetes, rheumatism, jaundice, malaria, asthma, depression, fever, fungal infections, and as an aphrodisiac. Components of Eurycoma longifolia have been found to have possibly beneficial biologic activities in animal models including hypoglycemic, diuretic, antioxidant, antiinflammatory, analgesic, antimalarial, antiviral, anticoagulant, hepatoprotective, immunomodulatory, antineoplastic, and aphrodisiac activities. Chemical analyses have demonstrated more than 65 compounds in extracts from Eurycoma longifolia including glycosaponins, quassinoids (eurycomanone, eurycomanols, eurycomalactones), canthine-6-one alkaloids, phenolic derivatives, coumarin, tannins, and triterpenes. It is not clear which of the identified compounds have the claimed biologic or clinical activities of tongkat ali either in animals or humans. Several studies in humans have shown mild increases in serum total testosterone levels in patients treated with tongkat ali, usually requiring several weeks for a full response and with no increase in free testosterone levels or in sex hormone binding globulin. The increases in testosterone levels have been generally associated with improved symptoms and mild increases in muscle strength in response to resistance training but have not been linked to improved athletic performance. Tongkat ali is available over the counter in various forms including raw powders, blends with tea or coffee, and capsules alone or in combination with other herbal products or dietary supplements. The typical dose in traditional medicine is 100 to 400 mg daily, but higher amounts (1,000 to 1,600 mg) are available in capsules sold online in products advertised as increasing testosterone levels, alleviating erectile dysfunction and “low T” syndrome as well as aiding body building and improving muscle strength. Side effects of tongkat ali in conventional doses are uncommon but may include nausea, abdominal discomfort, diarrhea, headaches, and rash. Its long term safety has not been well documented in humans.

### Hepatotoxicity

In small rather short term clinical studies of different preparations and concentrations of tongkat ali, adverse side effects were usually described as uncommon, unrelated to therapy, and minimal with no changes in serum ALT, AST, GGT or bilirubin levels. The effects of long term use and of higher doses, however, have not been assessed in humans. Furthermore, there is no standardization of purity and concentration of the extracts used. Recently, there have been isolated reports of clinically apparent liver injury in patients taking tongkat ali (Case 1). These reports have largely been in young male body builders and the possibility of unacknowledged anabolic steroid use weakens the evidence that the injury was due to Eurycoma longifolia.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Tongkat ali has multiple constituents and the chemical compounds that are possibly responsible for liver injury are not known. The clinical features of tongkat ali liver injury suggest that it is immunologically mediated. Cases may be more frequent and more severe in patients with preexisting liver disease and most clinical studies of tongkat ali have excluded patients with preexisting liver disease.

### Outcome and Management

Liver injury reported from tongkat ali has been self-limited in course and chronic injury has not been clearly described. At issue with most cases has been the possible role of unacknowledged anabolic steroid use or preexisting liver disease.

Drug Class: Herbal and Dietary Supplements

Other names: Eurycoma longifolia, Ali’s walking stick, Long Jack, Cay Ba Binh (Vietnam), Piak Saw (Thailand), Natural Viagra, Malaysian Ginseng

## CASE REPORT

### Case 1. Acute liver injury with jaundice attributed to a tongkat ali for body building.(1)

A 47 year old man developed upper abdominal discomfort, nausea and vomiting followed by dark urine and jaundice a week after starting a new herbal supplement for body building that contained tongkat ali. He was otherwise healthy except for hypertension. He was taking no other medications and denied a history of liver disease or risk factors for viral hepatitis. He drank alcohol socially and smoked cigarettes but denied drug abuse or use of other herbal medications. On examination he had normal vital signs except for hypertension and jaundice. Laboratory testing demonstrated a total bilirubin of 7.5 mg/dL, ALT 470 U/L, AST 234 U/L, Alk P 192 U/L, and INR 1.0 (R=7.5). Tests for hepatitis A, B and C were negative as were ANA and SMA. Abdominal ultrasound and computerized tomography (CT) were normal without evidence of gallstones or biliary dilatation. He was admitted to the hospital and the herbal supplement was withdrawn. Liver tests worsened for a few days and then began to improve (Table). He did not undergo liver biopsy and was not treated with corticosteroids.

#### Key Points

Medication: | Tongkat ali (Eurycoma longifolia) for 2 weeks, unknown dose
Pattern: | R=7.5 (hepatocellular)
Severity: | 3+ (jaundiced and hospitalized)
Latency: | 1 week
Recovery: | 1-2 months suspected
Other medications: | None reported

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | Pre | Started tongkat ali for bodybuilding
7 days | Pre | Developed nausea and abdominal pain
10 days | Pre | 470 | 192 | 7.5 | Emergency room
14 days | 0 | 875 | 238 | 14.3 | Admitted, supplement stopped
16 days | 2 days | 744 | 220 | 13.2
17 days | 3 days | 647 | 235 | 12.9 | Discharged
34 days | 20 days | 193 | 157 | 5.3 | Symptoms improved
Upper Limit of Normal | | 40* | 125* | 1.2

#### * Standard values

Comment

A 47 year old male body builder developed nausea, abdominal pain, and jaundice within a week or two of starting an herbal product containing tongkat ali. The injury was mildly hepatocellular and associated with moderate jaundice. The report lacked information on dose and had only partial follow up, not documenting whether full recovery occurred. This was the first published case of possible drug induced liver injury due to Eurycoma longifolia. While the clinical, laboratory, and radiologic evaluation was thorough in ruling out other causes of liver injury, an important cause to consider in body builders is the unacknowledged use of anabolic steroids. These products are illegal, of unknown purity and potency, and taken without medical supervision, often in excessive doses. The onset of liver injury and jaundice is usually after 1 to 3 months of taking anabolic steroids. Patients frequently do not admit to taking anabolic steroids and may specifically deny it. Itching is a frequent but not invariable symptom.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tongkat ali – Generic

DRUG CLASS

Herbal and Dietary Supplements

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Eurycomanone | 84633-29-4 | C20-H24-O9 | SID: 135254161

## CITED REFERENCE

1 Kaliounji A, Shadid G, Saba H, Ahlawat S. A rare case of Tongkat ali-induced liver injury: a case report. Cureus. 2024; 16: e56639.38646387

## ANNOTATED BIBLIOGRAPHY

References updated: 24 October 2024

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not tongkat ali).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of tongkat ali).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list tongkat ali among products associated with 5 or more reports). 19650152
Bhat R, Karim AA. Tongkat Ali (Eurycoma longifolia Jack): a review on its ethnobotany and pharmacological importance. Fitoterapia. 2010;81:669-79. (Review of the taxonomy, traditional uses, chemical composition, biologic activities, and safety of tongkat ali mentions that extracts of roots of the Eurycoma longifolia tree are used for increasing testosterone levels, but that there are no standards for purity of the plant extract or specific chemical component responsible for its activity and no available reports on the side effects of long term use). 20434529
Chen CK, Muhamad AS, Ooi FK. Herbs in exercise and sports. J Physiol Anthropol. 2012;31:4. (Review of the efficacy and safety of various herbal products in sports with mention of tongkat ali which has been shown to raise testosterone levels and increase sexual activity in rodents, but its effects in humans are less well established; no mention of ALT elevations during therapy or hepatotoxicity). 22738233
Tambi MI, Imran MK, Henkel RR. Standardised water-soluble extract of Eurycoma longifolia, Tongkat ali, as testosterone booster for managing men with late-onset hypogonadism? Andrologia. 2012;44 Suppl 1:226-30. (Description of controlled trials of Eurycoma longifolia extracts versus placebo in increasing athletic performance of professional cyclists, mentions two studies that showed no evidence of an effect on performance but also no evidence of toxicity). 21671978
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and herbal supplements but does not mention or list tongkat ali). 22928722
Li CH, Liao JW, Liao PL, Huang WK, Tse LS, Lin CH, Kang JJ, et al. Evaluation of acute 13-week subchronic toxicity and genotoxicity of the powdered root of Tongkat ali (Eurycoma longifolia Jack). Evid Based Complement Alternat Med. 2013;2013:102987. (Studies in rodents found no evidence of hepatic toxicity or elevations in serum ALT or AST from single doses or from 4- and 13-week daily therapy with Eurycoma longifolia root extracts in daily amounts of up to 2 gm/kg body weight). 24062779
Ulbricht C, Conquer J, Flanagan K, Isaac R, Rusie E, Windsor RC. An evidence-based systematic review of tongkat ali (Eurycoma longifolia) by the Natural Standard Research Collaboration. J Diet Suppl. 2013;10:54-83. (Extensive systematic review of the biologic activities, clinical efficacy, and safety of tongkat ali concludes that there is little information available on the adverse effects associated with Eurycoma longifolia; no discussion of hepatotoxicity or effects on ALT or AST levels). 23419023
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal, and traditional herbal remedies, but does not mention tongkat ali). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to tongkat ali). 25043597
Henkel RR, Wang R, Bassett SH, Chen T, Liu N, Zhu Y, Tambi MI. Tongkat Ali as a potential herbal supplement for physically active male and female seniors—a pilot study. Phytother Res. 2014;28:544-50. (Among 97 overweight or obese adults treated with an herbal product containing a blend of Citrus bergamia and Eurycoma longifolia [200 or 400 mg] or placebo once daily for 112 days, body mass index decreased with the herbal supplement by 1.0 kg/m^2^ vs an increase of 0.5 kg/m^2^ with placebo but without a change in lean body weight or fat mass and with no differences in changes in ALT, AST and GGT levels). 23754792
Chen CK, Mohamad WM, Ooi FK, Ismail SB, Abdullah MR, George A. Supplementation of Eurycoma longifolia Jack extract for 6 weeks does not affect urinary testosterone: epitestosterone ratio, liver and renal functions in male recreational athletes. Int J Prev Med. 2014;5:728-33. (Among 13 healthy male recreational athletes treated with Eurycoma longifolia extract [400 mg] or placebo once daily for 6 weeks with subsequent cross-over, there was no change in the testosterone: epitestosterone ratio and no changes in renal or liver tests). 25013692
Kreipke VC, Allman BR, Kinsey AW, Moffatt RJ, Hickner RC, Ormsbee MJ. Impact of four weeks of a multi-ingredient performance supplement on muscular strength, body composition, and anabolic hormones in resistance-trained young men. J Strength Cond Res. 2015;29:3453-65. (Among 27 young resistance trained men treated with a multi-ingredient product containing tongkat ali, beta alanine, branched chain amino acids, and a ”proprietary blend” versus placebo daily during a 4 week high intensity resistance training program, herbal treated patients showed greater increases in press weight [6 vs 5 kgs] and total weight lifted [34 vs 24 kgs] but no change in psychological or blood test results; no mention of testosterone, ALT or AST results). 26595135
Rehman SU, Choe K, Yoo HH. Review on a traditional herbal medicine, Eurycoma longifolia Jack (Tongkat ali): its traditional uses, chemistry, evidence-based pharmacology and toxicology. Molecules. 2016;21:331. (Review of the traditional use, chemistry, pharmacology, and toxicology of tongkat ali, mentions that it has been used as an aphrodisiac as well as treatment for malaria, fever, dysentery, and high blood pressure, and concludes that it has been shown to be safe when given in standard doses but that more information is needed on its safety). 26978330
Brown AC. Liver toxicity related to herbs and dietary supplements: online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss tongkat ali). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of tongkat ali or Eurycoma longifolia). 29307848
Balasubramanian A, Thirumavalavan N, Srivatsav A, Yu J, Hotaling JM, Lipshultz LI, Pastuszak AW. An Analysis of popular online erectile dysfunction supplements. J Sex Med. 2019;16:843-852. (Among the 6 most frequently ordered herbal products advertised for erectile dysfunction on Amazon, 5 had multiple ingredients, 3 of which contained tongkat ali). 31036522
Chen CK, Ooi FK, Abu Kasim NA, Asari MA. Effects of Eurycoma Longifolia Jack supplementation combined with resistance training on isokinetic muscular strength and power, anaerobic power, and urinary testosterone: epitestosterone ratio in young males. Int J Prev Med. 2019;10:118. (Among 40 healthy males ages 19 to 25 years treated with Eurycoma longifolia [200 mg] or placebo once daily with or without resistance training for 8 weeks, increase in muscle strength was found with resistance training but not with Eurycoma longifolia alone; no mention of adverse events). 31367282
Chinnappan SM, George A, Evans M, Anthony J. Efficacy of Labisia pumila and Eurycoma longifolia standardised extracts on hot flushes, quality of life, hormone and lipid profile of peri-menopausal and menopausal women: a randomised, placebo-controlled study. Food Nutr Res. 2020;64:3665. (Among 119 healthy women with menopausal symptoms treated with an herbal supplement with Labisia pumila and Eurycoma longifolia or with placebo, symptoms improved in both groups while ALT, AST and GGT levels remained within normal limits). 33061884
Brunetti P, Lo Faro AF, Tini A, Busardò FP, Carlier J. Pharmacology of herbal sexual enhancers: a review of psychiatric and neurological adverse effects. Pharmaceuticals (Basel). 2020;13: 309. (Review of literature on central nervous system adverse events of herbal sexual enhancers mentions that there were no reports on the psychiatric or neurological side effects of Eurycoma longifolia). 33066617
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; no mention of Eurycoma longifolia or tongkat ali). 34307603
Leitão AE, Vieira MCS, Gomes DA, Boing L, Pelegrini A, Luiz E, Guimarães ACA. Exercise associated or not to the intake of Eurycoma longifolia improves strength and cardiorespiratory fitness in men with androgen deficiency. Complement Ther Clin Pract. 2021;42:101301. (Among 37 men, ages 40 to 59 years, with androgen deficiency of aging who were randomized to receive Eurycoma longifolia [200 mg] or placebo daily combined with or without concurrent exercise training, muscular strength increased, and symptomatology improved in both groups with concurrent exercise training but there were no consistent differences with addition of Euryocoma longifolia). 33445146
Leitão AE, Vieira MCS, Pelegrini A, da Silva EL, Guimarães ACA. A 6-month, double-blind, placebo-controlled, randomized trial to evaluate the effect of Eurycoma longifolia (Tongkat Ali) and concurrent training on erectile function and testosterone levels in androgen deficiency of aging males (ADAM). Maturitas. 2021;145:78-85. (Among 105 adult men with low testosterone levels treated with an extract of roots of Eurycoma longifolia [100 or 200 mg] or placebo once daily for 12 weeks, total testosterone levels rose with herbal therapy compared to placebo as did improvements in symptoms and fatigue). 33541567
Chinnappan SM, George A, Pandey P, Narke G, Choudhary YK. Effect of Eurycoma longifolia standardised aqueous root extract-Physta^®^ on testosterone levels and quality of life in ageing male subjects: a randomised, double-blind, placebo-controlled multicentre study. Food Nutr Res. 2021;65:5647. (Among 105 men, ages 50 to 70 years, with low testosterone levels [<300 ng/dL] treated with an aqueous extract of Eurycoma longifolia roots [100 or 200 mg] vs placebo once daily for 12 weeks, symptom of fatigue improved and total testosterone levels increased in a dose dependent manner on the herbal extract [by 16 ng/dL and 25 ng/dL: +9% and +12.5% vs -3%], while free testosterone and sex hormone binding globulin levels were similar in all groups and serum ALT, AST, and bilirubin levels did not change). 34262417
Hancke J, Srivastava S, Caceres DD, Burgos RA, Alarcon P. An exploratory double-blind, randomized, placebo-controlled study to assess the efficacy of CitruSlim on body composition and lipid parameters in obese individuals. Phytother Res. 2021;35:7039-7049. (Among 97 overweight or obese adults treated with two doses of an herbal supplement containing Citrus begamia and Eurycoma longifolia vs placebo 3 times daily for 112 days, change in mean BMIs were -1.0 on the supplement vs +0.5 on placebo without differences in lean body mass or percent body fat, while therapy was well tolerated and serum levels of ALT, AST and Alk P did not change). 34794202
EFSA Panel on Nutrition, Novel Foods and Food Allergens (NDA); Turck D, Bohn T, Castenmiller J, De Henauw S, Hirsch-Ernst KI, Maciuk A, Mangelsdorf I, et al. Safety of Eurycoma longifolia (Tongkat Ali) root extract as a novel food pursuant to Regulation (EU) 2015/2283. EFSA J. 2021;19:e06937. (Analysis of the safety of Eurycoma longifolia root extract as a food supplement by the European Food Safety Commission [EFSA] expressed concern that the herbal supplement induced evidence of DNA damage and concluded that its “safety has not been established under any condition of use”). 34987621
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while tongkat ali was not mentioned). 33434654
Zakaria AZ, Washif JA, Lim BH, Nosaka K. Effects of Eurycoma longifolia Jack supplementation on eccentric leg press exercise-induced muscle damage in rugby players. Biol Sport. 2023;40:691-697. (Among 18 young male Rugby players treated with Eurycoma longifolia [400 mg] or placebo daily for 7 days before performing repeated leg press exercises to failure, there were no differences between the two groups in peak force, strength, muscle soreness, and CPK elevations, and salivary testosterone levels did not change; no mention of adverse events or serum ALT or AST elevations). 37398958
Kaliounji A, Shadid G, Saba H, Ahlawat S. A rare case of tongkat ali-induced liver injury: a case report. Cureus. 2024;16:e56639. (47 year old man developed abdominal pain and jaundice one week after starting a new herbal supplement containing tongkat ali [bilirubin 7.5 rising to 14.1 mg/dL, ALT 470 U/L, Alk P 192 U/L], resolving after stopping: Case 1). 38646387

## OTHER REFERENCE LINKS

1. Recent References on Tongkat ali: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tongkat+ali+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Tongkat ali: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tongkat%20ali)